# Enfortumab Vedotin

## OVERVIEW

### Introduction

Enfortumab vedotin is a human monoclonal antibody conjugate that is used in the therapy of refractory, locally advanced or metastatic urothelial cancer. Enfortumab vedotin has been linked to transient, mild-to-moderate serum enzyme elevations during therapy but has not been implicated in instances of clinically apparent liver injury with jaundice.

### Background

Enfortumab (en for’ tue mab) vedotin (ve doe’ tin) is a human monoclonal antibody to Nectin-4, a cell adhesion molecule that is highly expressed on urothelial carcinoma cells and that appears to contribute to cancerous cell growth and proliferation. The monoclonal antibody is conjugated using a linker sequence to a cytotoxic molecule, vedotin monomethyl auristatin E (MMAE) that disturbs microtubule formation resulting in cell-cycle arrest and apoptosis. When enfortumab binds to Nectin-4, it is internalized and the vedotin is released by the action of lysosomal enzymes, which cleave the short linker molecule that joins the antibody and the cytotoxic molecule. Once released, the intracellular vedotin binds to microtubules preventing their participation in cell division resulting in apoptotic cell death of the rapidly dividing malignant urothelial cells. This monoclonal antibody conjugate has been shown to be effective in inducing remissions in patients with locally advanced or metastatic urothelial cancer who previously have been treated with platinum-containing regimens and check point inhibitors. Combined with pembrolizumab (a check point inhibitor monoclonal antibody to PD-1), enfortumab vedotin also demonstrated efficacy in patients with advanced or metastatic urothelial cancer who are not eligible to receive the cisplatin-containing regimens. Enfortumab vedotin was given accelerated approval for these indications in the United States in 2019. It is available as lyophilized powder for reconstitution in single dose vials of 20 and 30 mg under the brand name Padcev. The typical recommended dose regimen is 1.25 mg/kg (up to 125 mg) administered by intravenous infusion on days 1, 8 and 15 of 28-day cycles or (when given with pembrolizumab) on days 1 and 8 of 21-day cycles and continued until disease progression or unacceptable toxicity. Side effects are common and may include infusion reactions, nausea, abdominal pain, anorexia, weakness, fatigue, headache, dizziness, itching, alopecia, peripheral neuropathy, dry eyes, dry skin, and rash. Enfortumab vedotin can also cause myelosuppression and decreases in hemoglobin, white cells, and platelets, as well as increases in liver enzymes, creatinine, urate, and lipase. Less common, but potentially serious side effects include peripheral neuropathy, hypersensitivity reactions, severe myelosuppression, pneumonia, interstitial lung disease, and fetal-embryonal toxicity. Enfortumab vedotin should be administered only by physicians with training and expertise in cancer chemotherapy and management of its potential adverse effects.

### Hepatotoxicity

In preregistration trials of enfortumab vedotin, serum aminotransferase elevations occurred in 20% to 40% of patients with ALT levels above 5 times ULN in only 3%, leading to dose interruptions in 2% and permanent discontinuations in 1%. Nevertheless, there were no instances of clinically apparent liver injury with jaundice. The product label for enfortumab vedotin mentions ALT and AST elevations as occurring during therapy, which are probably more frequent in those who are also receiving pembrolizumab. After its approval and more widespread use, there have been no instances of clinically apparent liver injury reported in the literature, but several instances of suspected liver injury from enfortumab vedotin have been reported to the FDA.

Likelihood score: E* (suspected but unproven cause of clinically significant liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations during enfortumab vedotin therapy is not known, but it is likely due to direct toxicity of the vedotin conjugate rather than the monoclonal antibody. Because enfortumab vedotin is sometimes given with pembrolizumab, instances of immune mediated liver injury are likely to occur with therapy, but probably are due to the checkpoint inhibitor rather than the monoclonal conjugate.

### Outcome and Management

The product label for enfortumab vedotin does not recommend routine monitoring of liver tests, and aminotransferase elevations that occur with therapy are generally transient, mild and asymptomatic and rarely require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal, if detected, should lead to more careful monitoring and suspension of further infusions, at least until levels return to normal or near normal levels. Elevations above 20 times the ULN or any elevation accompanied by jaundice or symptoms should lead to prompt permanent discontinuation.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies,

Other Monoclonal Antibody Conjugates: Ado-Trastuzumab Emtansine, Benlantamab Mafodotin, Brentuximab Vedotin, Gemtuzumab Ozogamicin, Inotuzumab Ozogamicin, Polatuzumab Vedotin, Sacituzumab Govitecan, Tisotumab Vedotin, Trastuzumab Deruxtecan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Enfortumab Vedotin – Padcev®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Enfortumab%20Vedotin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Enfortumab Vedotin | 1346452-25-2 (https://pubchem.ncbi.nlm.nih.gov/compound/Enfortumab-Vedotin) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 November 2023

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/761137Orig1s000MultiDiscliplineR.pdf (FDA website with product labels and initial multidiscipline review of enfortumab vedotin mentions that in the total safety cohort of 310 patients, ALT elevations occurred in 34% of patients and were above 5 times ULN in 3%, led to dose interruption in 2%, and discontinuation in 1% but there were no cases of clinically apparent liver injury with jaundice attributed to therapy).
Rosenberg JE, O'Donnell PH, Balar AV, McGregor BA, Heath EI, Yu EY, Galsky MD, et al. Pivotal trial of enfortumab vedotin in urothelial carcinoma after platinum and anti-programmed death 1/programmed death ligand 1 therapy. J Clin Oncol. 2019;37:2592-2600. (Among 125 patients with refractory or relapsed, locally advanced or metastatic urothelial cancer treated with enfortumab vedotin, the objective response rate was 44%, while adverse events occurred in most patients including fatigue in 50%, alopecia 49%, decreased appetite 44%, dysgeusia 40%, and peripheral neuropathy 40%, leading to dose reductions in 32% and discontinuation in 12%; ALT elevations arose in 20% that were above 5 times ULN in 2). 31356140
Joubert N, Beck A, Dumontet C, Denevault-Sabourin C. Antibody-drug conjugates: the last decade. Pharmaceuticals (Basel). 2020;13:245. (Review of the development, structure, efficacy, adverse event rates and approval of vector-based chemotherapy using selective delivery by a monoclonal antibody and cancer cell injury by a conjugated cellular toxin [payload] including nine that are FDA approved and six others in pivotal trials). 32937862
Powles T, Rosenberg JE, Sonpavde GP, Loriot Y, Durán I, Lee JL, Matsubara N, et al. Enfortumab vedotin in previously treated advanced urothelial carcinoma. N Engl J Med. 2021;384:1125-1135. (Among 608 patients with refractory, locally advanced or metastatic urothelial carcinoma treated with enfortumab vedotin [1.25 mg/kg on days 1, 8 and 15 of 28-day cycles] or standard chemotherapy, median overall survival was 13 vs 9 months and overall response rates were 41% vs 18%, and while adverse event rates were similar, enfortumab treated subjects had a higher rate of serious adverse events [46% vs 44%], peripheral sensory neuropathy {46% vs 31%], hyperglycemia [6.4% vs 0.3%], and withdrawal of therapy for ALT elevations [2% vs 0.3% ]; one patient receiving enfortumab died of hepatic dysfunction [no details provided]). 33577729
Yu EY, Petrylak DP, O'Donnell PH, Lee JL, van der Heijden MS, Loriot Y, Stein MN, et al. Enfortumab vedotin after PD-1 or PD-L1 inhibitors in cisplatin-ineligible patients with advanced urothelial carcinoma (EV‑201): a multicentre, single-arm, phase 2 trial. Lancet Oncol. 2021;22:872-882. (Among 89 adults with advanced urothelial carcinoma refractory to therapy with PD-L1 or PD-1 and who were ineligible for cisplatin and were treated with enfortumab vedotin, the overall response rate was 52% and progression free survival 5.8 months, while adverse events were frequent including alopecia in 53%, sensory peripheral neuropathy 44%, ALT elevations 7%, and which were above 5 times ULN in 1%). 33991512
Hoimes CJ, Flaig TW, Milowsky MI, Friedlander TW, Bilen MA, Gupta S, Srinivas S, et al. Enfortumab vedotin plus pembrolizumab in previously untreated advanced urothelial cancer. J Clin Oncol. 2023;41:22-31. (Among 45 adults with advanced or metastatic urothelial cancer ineligible to receive cisplatin who were treated with enfortumab vedotin and pembrolizumab, the objective response rate was 73% and adverse events were considered “manageable”, with sensory neuropathy developing in 56%, fatigue in 51%, alopecia in 49%, and ALT elevations in 20%, none of which were above 5 times ULN or associated with symptoms or jaundice). 36041086
Fu Z, Gao C, Wu T, Wang L, Li S, Zhang Y, Shi C. Peripheral neuropathy associated with monomethyl auristatin E-based antibody-drug conjugates. iScience. 2023;26:107778. (Rates of peripheral neuropathy are higher with antineoplastic monoclonal antibody conjugates with microtubule inhibitors such as vedotin compared to other cytotoxins, overall rates ranging from 8% to 66%, severe rates from <1% to 12%, caused probably by release of the monomethyl auristatin E toxin from the targeted cells to the systemic circulation or by direct uptake of the monoclonal conjugate by peripheral nerve Schwann cells). 37727735
Sun C, Yang X, Tang L, Chen J. A pharmacovigilance study on drug-induced liver injury associated with antibody-drug conjugates (ADCs) based on the Food and Drug Administration Adverse Event Reporting System. Expert Opin Drug Saf. 2023 Oct 29:1-12. Epub ahead of print. (Analysis of the FDA reporting system [FAERS] for cases of drug induced liver injury submitted between 2004 and 2022, found 17,784 reports, 504 [3%] attributed to antibody-drug conjugates, 202 from the US, the implicated agents being gemtuzumab ozogamicin [n=98], brentuximab vedotin [n=37], trastuzumab emtansine [n=25], enfortumab vedotin [n=16], inotuzumab ozogamicin [n=15], transtuzumab deruxtecan [n=8], and polatuzumab vedotin [3]). 37898875

## OTHER REFERENCE LINKS

Recent References on Enfortumab Verdotin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Enfortumab+AND+Verdotin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Enfortumab Verdotin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Enfortumab%20Verdotin)